# Vorapaxar

## OVERVIEW

### Introduction

Vorapaxar is an inhibitor of platelet aggregation that is used to decrease the risk of further cardiovascular thrombotic events in patients with a history of myocardial infarction or peripheral vascular disease. Vorapaxar therapy is associated with a low rate of serum aminotransferase elevations, but has not been linked to instances of clinically apparent acute liver injury.

### Background

Vorapaxar (vor" a pax' ar) is an inhibitor of the protease-activated receptor 1 (PAR-1) that is found on platelets and is activated by thrombin resulting in platelet aggregation and formation of a vascular clot. The aggregation of platelets also plays an important role in the growth of atheromatous plaques, which can lead to coronary, cerebral and peripheral arterial occlusions. In large clinical trials, vorapaxar therapy has been shown to decrease the frequency of recurrence of myocardial infarction and cardiovascular events in patients at high risk of complications of atherosclerosis. Vorapaxar was approved for use in the United States in 2014 and current indications are for reduction of atherosclerotic events (myocardial infarction, vascular death) in patients with a history of myocardial infarction or peripheral vascular disease. Vorapaxar is contraindicated in patients with a history of stroke or transient ischemic attacks because of an increased risk of intracerebral bleeding. Vorapaxar is available in 2.08 mg tablets under the brand name Zontivity. The usual dose is one tablet (2.08) mg daily. Side effects are not common, but can include headache, dizziness, fatigue, gastrointestinal upset, nausea, arthralgia and rash. Uncommon, but potentially severe adverse reactions including bleeding and particularly intracerebral bleeding in patients with a history of stroke.

### Hepatotoxicity

Vorapaxar is associated with a low rate of serum enzyme elevations during therapy that was similar to the rate that occurred with placebo or comparator therapies. In a large controlled trial in over 10,000 patients monitored over a 2 year period, ALT elevations above 5 times the upper limit of normal occurred in 1% of vorapaxar vs 1.4% of placebo patients. In pooled analyses of laboratory studies from more than 39,000 patients receiving vorapaxar or placebo, GGT was the only liver test that was abnormal in a higher proportion of patients receiving vorapaxar (3.8%) than placebo (3.3%), and there were no reports of liver related serious adverse events or clinically apparent liver injury. Thus, liver injury from vorapaxar must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which vorapaxar might cause liver injury is not known. It is metabolized in the liver, largely via CYP 3A4 and is susceptible to drug-drug interactions, particularly with potent inhibitors or induces of CYP 3A activity.

### Outcome and Management

There is little evidence that cangrelor can cause liver injury or has any cross sensitivity to other antiplatelet agents.

Drug Class: Antithrombotic Agents, Antiplatelet Agents

Other Drugs in the Subclass, Antiplatelet Agents: Aspirin, Cangrelor, Clopidogrel, Dipyridamole, Prasugrel, Ticagrelor, Ticlopidine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vorapaxar – Generic, Zontivity®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Vorapaxar)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Vorapaxar | 618385-01-6 | C29-H33-F-N2-O4 | Vorapaxar chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 April 2017

Zimmerman HJ. Platelet aggregation inhibitors. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 641-3. (Textbook of hepatotoxicity published in 1999 discusses ticlopidine, but not vorapaxar).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs: antihypertensives. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 528. (Review of hepatotoxicity of antiplatelet drugs; does not discuss vorapaxar).
Weitz JI. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 849-76. (Textbook of pharmacology and therapeutics).
Becker RC, Moliterno DJ, Jennings LK, Pieper KS, Pei J, Niederman A, Ziada KM, et al.; TRA-PCI Investigators. Safety and tolerability of SCH 530348 in patients undergoing non-urgent percutaneous coronary intervention: a randomised, double-blind, placebo-controlled phase II study. Lancet 2009; 373 (9667): 919-28. (Among 1060 patients undergoing percutaneous coronary intervention given a loading dose followed by oral vorapaxar for 60 days or placebo, clinically significant bleeding occurred at similar rates in all groups; other adverse events were not discussed). 19286091
Morrow DA, Braunwald E, Bonaca MP, Ameriso SF, Dalby AJ, Fish MP, Fox KA, et al.; TRA 2P–TIMI 50 Steering Committee and Investigators. Vorapaxar in the secondary prevention of atherothrombotic events. N Engl J Med 2012; 366: 1404-13. (Among 26,449 patients with a history of myocardial infarction, stroke or peripheral artery disease treated with vorapaxar [2.5 mg daily] or placebo for a median of 30 months, cardiovascular endpoints were less in the vorapaxar treated group, but moderate-to-severe bleeding episodes [4.2% vs 2.5%] and intracranial hemorrhage [1% vs 0.5%] were more common; other adverse events were not discussed). 22443427
Tricoci P, Huang Z, Held C, Moliterno DJ, Armstrong PW, Van de Werf F, White HD, et al.; TRACER Investigators. Thrombin-receptor antagonist vorapaxar in acute coronary syndromes. N Engl J Med 2012; 366: 20-33. (Among 12,944 patients with acute coronary syndromes treated with vorapaxar or placebo for 1-2 years, intracranial hemorrhage was more frequent with vorapaxar [1.1% vs 0.2%], while other adverse events were similar including any ALT elevations [5.4% vs 6.4%] and those above 5 times ULN [1.0 % vs 1.4%]). 22077816
Vorapaxar (Zontivity) for prevention of thrombotic cardiovascular events. Med Lett Drugs Ther 2014; 56 (1451): 85-6. (Concise review of the mechanism of action, clinical efficacy, safety and costs of vorapaxar shortly after its approval for use in the US; mentions side effects of bleeding, but does not mention ALT elevations or hepatotoxicity). 25211301
Magnani G, Bonaca MP, Braunwald E, Dalby AJ, Fox KA, Murphy SA, Nicolau JC, et al. Efficacy and safety of vorapaxar as approved for clinical use in the United States. J Am Heart Assoc 2015; 4 (3): e001505. (Secondary analysis of TRA-2P TIMI 50 [Morrow 2012] limiting cohorts to patients without a history of stroke found reduced rates of cardiovascular endpoints at 3 years with vorapaxar therapy compared to placebo [7.9% vs 9.5%]). 25792124
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to vorapaxar or other antiplatelet drugs). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Vorapaxar: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=aspirin/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/5/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. : from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=aspirin) Trials on Vorapaxar: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=aspirin)